# Apomorphine

## OVERVIEW

### Introduction

Apomorphine is a subcutaneously administered dopamine receptor agonist used predominantly in the therapy of hypomobility of advanced Parkinson disease. The use of apomorphine has been limited, but it has not been associated with serum enzyme elevations during treatment nor has it been implicated in cases of acute liver injury.

### Background

Apomorphine (a" poe mor' feen) is a subcutaneously administered dopamine receptor agonist which has moderate affinity for the D2, D3, and D5 class of dopamine receptors in the central nervous system and little activity against the D1 class. It also has some alpha adrenergic activity. Apomorphine was shown to improve motor function in animal models of Parkinson disease and in clinical trials, was shown to decrease hypomobility in patients with advanced Parkinsonism. Apomorphine was approved for use in the United States in 2004, but had been used in Europe for more than a decade. Current indications are for acute and intermittent treatment of hypomobility of advanced Parkinson disease. It is also used for acute dystonic reactions. Apomorphine is available in a liquid solution of 10 mg/mL under the brand name Apokyn. It is given in 0.2 to 0.6 mL doses subcutaneously as needed up to 3 times daily. Apomorphine injections usually cause nausea and vomiting requiring antiemetics. It can cause hypotension, gastrointestinal upset, anxiety, confusion, dizziness, headache, hallucinations, vivid dreams and insomnia, symptoms typical of dopaminergic stimulation.

### Hepatotoxicity

Apomorphine has not been reported to cause serum aminotransferase elevations or clinically apparent acute liver injury, but its use has been limited and is typically given in low doses for a limited period of time. Thus, if apomorphine causes liver injury it must be rare.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The metabolism of apomorphine has not been well defined; it appears to be minimally metabolized in the liver.

Drug Class: Antiparkinson Agents

Other Drugs in the Subclass, Dopamine Receptor Agonists: Bromocriptine, Pergolide, Pramipexole, Ropinirole, Rotigotine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Apomorphine – Apokyn®

DRUG CLASS

Antiparkinson Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Apomorphine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Apomorphine | 58-00-4 | C17-H17-N-O2 | Apomorphine Chemical Structure

## REFERENCES

References updated: 20 July 2017

Zimmerman HJ. Antiparkinsonism drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715-7. (Expert review of hepatotoxicity published in 1999; among anticholinergic agents, "only trihexyphenidyl has been incriminated in hepatic injury"; other antiparkinsonism drugs discussed include levodopa, lergotrile [no longer available], pergolide and bromocriptine).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of hepatotoxicity of agents acting on the central nervous system).
Standaert DG, Roberson ED. Treatment of central nervous system degenerative disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 609-28. (Textbook of pharmacology and therapeutics).
McDowell F. Symposium on levodopa in Parkinson's disease. Clinical and pharmacological aspects. Clinical laboratory abnormalities. Clin Pharmacol Ther 1971; 12: 335-9. (Retrospective analysis of laboratory abnormalities arising in 974 patients with Parkinson disease treated with levodopa; AST elevations occurred in 9% of 5427 determinations, but were usually mild and transient returning to normal in 1-2 months without dose adjustment; AST levels rose to 1600 U/L in one patient who later died of complications of diabetes). 4102803
Pinter MM, Helscher RJ, Mundsperger N, Binder H. Transient increase of pancreatic enzymes evoked by apomorphine in Parkinson's disease. J Neural Transm 1998; 105: 1237-44. (Among 29 patients with Parkinson disease treated with apomorphine, transient asymptomatic elevations in amylase and lipase elevations occurred in 5; liver enzymes remained normal). 9928892
Lambert D, Waters CH. Comparative tolerability of the newer generation antiparkinsonian agents. Drugs Aging 2000; 16: 55-65. (Review of mechanism of action, tolerability and safety of selegiline, pramipexole, ropinirole, tolcapone and entacapone in Parkinson disease). 10733264
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to agents used for Parkinson disease). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25,1425. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to an agent used to treat Parkinson disease). 23419359
Drugs for Parkinson's disease. Treat Guidel Med Lett 2013; 11 (135): 101-6. (Concise review of recommendations for therapy of Parkinson disease with description of mechanisms of action, efficacy and adverse events). 24165688
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an agent to treat Parkinson disease). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to an agent used to treat Parkinson disease). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Apomorphine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Apomorphine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Apomorphine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Apomorphine)